# Allopurinol

## OVERVIEW

### Introduction

Allopurinol is a xanthine oxidase inhibitor and a widely used medication for gout. Allopurinol is a rare but well known cause of acute liver injury that has features of a hypersensitivity reaction and can be severe and even fatal.

### Background

Allopurinol (al' oh pure' i nol) is an analog of hypoxanthine and a potent inhibitor of the enzyme xanthine oxidase that is responsible for converting hypoxanthine to xanthine and xanthine to uric acid in the breakdown pathway of purines. Allopurinol lowers serum and tissue uric acid levels and has potent activity against gout, largely in preventing rather than treating acute attacks of gout. Allopurinol was approved for use in the United States in 1963 and is still widely used. Current indications include therapy and prevention of symptomatic gout, uric acid nephropathy, and the hyperuricemia caused by malignancy and anticancer therapy. It is not recommended for treatment of asymptomatic hyperuricemia. Allopurinol is available in multiple generic forms and under the brand name of Zyloprim or Aloprim in tablets of 100 and 300 mg. Intravenous formulations are also available. The recommended initial dose for therapy of gout is 100 mg daily, with increases of 100 mg in daily dose weekly until uric acid levels fall to 6 mg/dL or below, but not to exceed 800 mg daily. The average daily dose in therapy of gout is 300 mg. Common side effects include skin rash and hypersensitivity reactions. Rare but potentially severe adverse events include severe cutaneous reactions including drug reaction with eosinophilia and systemic symptoms (DRESS) syndrome, Stevens Johnson Syndrome (SJS), and toxic epidermal necrolysis (TEN).

### Hepatotoxicity

Chronic therapy with allopurinol is associated with transient and minor liver test abnormalities in 2% to 6% of patients, which resolve spontaneously or with drug discontinuation. More importantly, allopurinol has been linked to a very distinctive form of acute liver injury that is accompanied by prominent immunoallergic manifestations such as fever, rash, eosinophilia, lymphadenopathy, atypical lymphocytosis, thrombocytopenia, arthralgias and facial edema (drug reaction with eosinophilia and systemic symptoms — DRESS syndrome) (Case 1). The typical latency to onset is 2 to 8 weeks and liver injury arising during long term therapy is uncommon. The pattern of liver enzyme elevations tends to be mixed, but can be hepatocellular or purely cholestatic. Autoantibodies are not common. In some cases, rash and fever arise before evidence of liver injury, and elevations in serum enzymes and bilirubin occur 1 to 2 weeks after the first immunoallergic manifestations. Eosinophilia in addition may arise only after the clinical manifestations. The systemic symptoms and signs of DRESS syndrome caused by allopurinol can also be manifested by renal, pulmonary, or pancreatic dysfunction and even acalculous cholecystitis. More severe forms of allopurinol hypersensitivity reactions include Stevens Johnson syndrome (SJS) and toxic epidermal necrolysis (TEN), both of which are commonly accompanied by signs of liver injury, although the liver injury is often mild and transient serum aminotransferase elevations without jaundice. Overall, allopurinol hypersensitivity reactions have a high fatality rate, either from acute liver failure, chronic cholestatic injury or complications of other allergic manifestations such as toxic epidermal necrolysis, vasculitis, pancreatitis, and renal dysfunction. The incidence of acute, symptomatic liver injury due to allopurinol is estimated to be between 1 in 4,000 to 1 in 5,000 persons newly started on therapy. African and Asian ancestry and preexisting renal disease appear to be important risk factors for hypersensitivity reactions to allopurinol.

Likelihood score: A (well established cause of clinically apparent liver injury).

#### Histopathology

Liver biopsy in allopurinol hepatotoxicity typically shows an acute cholestatic or mixed hepatitis. Bile duct injury may be prominent early and loss of bile ducts later during the course. Histology can also show granulomas including "ring" granulomas that are typically associated with visceral infections such as Q fever or Kala-azar. Granulomas may be found in other organs as well and represent a typical histological correlate to the immunoallergic response to a medication. Two examples of the histology of allopurinol hepatotoxicity are shown below: one with a cholestatic hepatitis and another with acute granulomatous changes.

CHOLESTATIC HEPATITIS

| Allopurinol may cause cholestatic hepatitis. This case shows canalicular (arrow) and hepatocellular cholestasis in zone 3. Only very mild inflammation is present in this photo. The central vein (V) is indicated.
| In this case, there was mild portal inflammation, mainly composed of lymphocytes. In over half the portal areas, no duct could be found, consistent with a vanishing bile duct syndrome. This portal area only shows an artery (A) and vein (V).

GRANULOMATOUS HEPATITIS

| This case had granulomas in almost all of the portal areas. In this portal, the epithelioid macrophages (arrow) of the granulomas are in the center part of the portal area. The granuloma is surrounded by a mixed inflammatory infiltrate of lymphocytes, neutrophils and eosinophils. A cluster of eosinophils is indicated by the arrowhead.
| Another portal area showing a granuloma (arrow) along with mixed inflammation.
| A fibrin‐ring granuloma was present in this case. A fibrin‐ring granuloma is a granuloma that forms around a lipid droplet (L). A thin, irregular, ring of brightly eosinophilic fibrin can be seen running circumferentially around the lipid drop. It is best seen at the bottom (arrow).

### Mechanism of Injury

The mechanism of allopurinol hepatotoxicity is believed to be immunoallergic. Many cases resemble those of anticonvulsant hypersensitivity. Recently, several cases have been linked to concurrent infection with human herpesvirus-6, EBV or CMV infections. Severe allopurinol hypersensitivity skin and liver reactions have been closely linked to HLA B*58:01 particularly in Asian populations but also to a lesser extend in Caucasians and African Americans, in whom there are also associations HLA-B*53:01 and A*34.02. These HLA associations are less common in cases of allopurinol liver injury without DRESS syndrome or SJS/TEN.

### Outcome and Management

While most cases of acute liver injury attributed to allopurinol are self-limited and start to resolve within 7 to 10 days of stopping the medication, other cases are protracted, severe and even fatal. Instances of chronic vanishing bile duct syndrome due to allopurinol have been reported. Because of the accompanying allergic manifestations, corticosteroids are often used and usually result in prompt improvements in fever and rash, but their efficacy in ameliorating the liver injury is unproven. Relapse with early discontinuation of corticosteroids is common. There is no known cross reactivity of hypersensitivity to allopurinol with similar reactions to other medications, including the anticonvulsants.

Drug Class: Antigout Agents

## CASE REPORTS

### Case 1. DRESS syndrome accompanied by acute liver failure due to allopurinol.(1)

A 58 year old woman with diabetes, hypertension, gastric ulcer and gouty arthritis with hyperuricemia and mild renal insufficiency was started on allopurinol (300 mg daily) and developed fever and rash 17 days later. She had undergone resection of a parathyroid adenoma under enflurane anesthesia shortly after starting allopurinol, but she recovered uneventfully and was sent home on doxycycline, in addition to her usual medications including glibenclamide, indomethacin and cimetidine. One week later, she developed fever, fatigue and rash which became generalized and exfoliative. Allopurinol was stopped and she was admitted for observation. She was markedly febrile (39^o^C) and had a generalized erythematous rash. Blood testing showed leukocytosis and eosinophilia. Liver tests, which were previously normal, were mildly elevated on admission, but over the next few days worsened with onset of jaundice (Table). Tests for hepatitis A and B were negative. She subsequently developed progressive prolongation of the prothrombin time followed by confusion, encephalopathy and ascites. Corticosteroids were started. She developed gram negative sepsis followed by multiorgan failure and died. Postmortem liver biopsy showed marked centrilobular necrosis, cholestasis, inflammation and small islands of regenerating hepatocytes.

#### Key Points

Medication: | Allopurinol (300 mg daily)
Pattern: | Mixed (R=2.2)
Severity: | 5+ (death from hepatic failure)
Latency: | 3 weeks
Recovery: | None
Other medications: | Glibenclamide, indomethacin, and cimetidine chronically. Enflurane 2 weeks before onset, doxycycline for the 6 days before onset.

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Allopurinol started (300 mg daily) for gout
4 days | | 25 | 100 | 0.5 | Preoperative testing
17 days | 0 | 110 | 120 | 0.5 | Admission: rash and fever
4 weeks | 11 days | 1240 | 1240 | 12.0 | Prothrombin time 9 sec prolonged
6 weeks | 25 days | 65 | 390 | 30.0 | Ascites, coma and sepsis
Normal Values | | <40 | <95 | <1.2

#### Comment

This patient developed typical allopurinol hypersensitivity syndrome 3 weeks after starting therapy. Risk factors included preexisting renal insufficiency. Several days after being admitted for rash and fever, she developed jaundice and had subsequent worsening with development of hepatic failure. This syndrome is also referred to as DRESS (drug rash with eosinophilia and systemic symptoms) and is usually rapidly reversible with stopping the medication. However, the hypersensitivity reaction can be severe and result in death from acute liver failure or from complications of generalized skin rash (toxic epidermal necrolysis) or renal disease. Corticosteroid therapy is often given and usually results in rapid disappearance of fever and improvement in rash, but relapse with stopping corticosteroids is common and this therapy is of unproven benefit for the hepatic injury and can complicate management of acute liver failure. Severe cutaneous reactions to allopurinol have been linked to HLA B*58:01 and cases of hepatotoxicity with allergic manifestations and skin rash are likely to have a similar linkage.

### Case 2. DRESS syndrome and mixed hepatitis due to allopurinol.(2)

A 61 year old African American woman with diabetes, hypertension, chronic congestive heart failure, obesity, chronic renal dysfunction, and asthma was started on gradually increasing doses of allopurinol for gout. Approximately 11 weeks later, she developed fatigue, followed by rash, fever and facial swelling. She had no history of liver disease or risk factors for viral hepatitis and did not drink alcohol. Her other medications included metformin, amlodipine, metoprolol, clonidine, furosemide, iron, fluticasone with salmeterol, warfarin and aspirin, all of which she had been taking for several years. On examination, she had fever to 39.2 ^o^C and a diffuse maculopapular rash. Blood testing showed leukocytosis and eosinophilia and worsening of her chronic renal dysfunction. A skin biopsy showed vacuolar interface dermatitis and eosinophils consistent with a drug reaction. Initially, liver tests were normal or only minimally elevated with bilirubin 0.3 mg/dL, ALT 89 U/L and Alk P 102. Despite stopping allopurinol promptly, however, her liver tests worsened over the ensuing week, with bilirubin rising to 7.7 mg/dL, ALT to 414 U/L and Alk P to 243 U/L. Tests for hepatitis A, B, C and E, Epstein Barr virus and cytomegalovirus infection were negative as were ANA, SMA, and AMA. Abdominal ultrasound and magnetic resonance imaging showed no evidence of gallstones or biliary dilation. She was treated with prednisone and her fever and rash improved but bilirubin worsened. A liver biopsy showed bland cholestasis, minimal inflammation, no duct loss, and no fat or fibrosis. Serum bilirubin rose to a peak of 23.7 mg/dL and INR to 1.7 and she developed worsening renal function. Serum bilirubin levels remained above 16 mg/dL and she developed pneumonia followed by progressive multiorgan failure and died 8 weeks after initial presentation.

#### Key Points

Medication: | Allopurinol (100 to 800 mg daily)
Pattern: | Mixed (R=3.9)
Severity: | 5+ (death from multiorgan failure)
Latency: | 10 weeks
Recovery: | None
Other medications: | Metformin, amlodipine, metoprolol, clonidine, furosemide, warfarin, aspirin, iron, fluticasone with salmeterol

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Allopurinol started (100 to 800 mg daily) for gout
11 weeks | 0 | 89 | 102 | 0.3 | Rash and fever
3 months | 9 days | 331 | 220 | 0.5
| 13 days | 430 | 234 | 5.6
| 16 days | 414 | 243 | 7.7 | US: normal
| 23 days | 273 | 289 | 10.7 | MRI: normal
| 33 days | 158 | 512 | 16.1 | INR 1.6
4 months | 37 days | 132 | 438 | 16.8 | INR 1.2
| 41 days | 146 | 482 | 23.7
| 48 days | 165 | 262 | 16.1
| 55 days | 172 | 295 | 19.6
5 months | 56 days | | | | Died: multiorgan failure
Normal Values | | <45 | <35 | <1.2

#### Comment

This patient developed DRESS syndrome 11 weeks after starting allopurinol therapy of gradually increasing doses. Risk factors included preexisting renal insufficiency and African American race. Several days after being admitted for rash and fever, she developed worsening jaundice which did not respond to withdrawal of allopurinol or systemic corticosteroid therapy. Her persistent jaundice and downhill course appeared to be exacerbated by renal insufficiency and infectious and metabolic complications of high dose corticosteroids. Her death from multiorgan failure was not directly related to the liver injury, but the hepatic dysfunction definitely contributed to the poor outcome. Typical of this case was the onset of jaundice a week or two after onset of the rash and fever. Atypical was the somewhat long latency, the usual latency for allopurinol hypersensitivity reactions being 3 to 4 weeks. Testing of stored blood demonstrated that she was heterozygous for HLA-B*58:01, a known risk factor for allopurinol induced severe cutaneous reactions (both DRESS and Stevens-Johnson syndrome). The HLA type is relatively common among Chinese subjects (allele frequency [AF]: 0.09), less common among African Americans (AF: 0.04) and rare in European Americans (AF: <0.01), perhaps accounting for the racial differential in susceptibility to allopurinol hypersensitivity reactions with low rates among white populations.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Allopurinol – Generic, Aloprim®, Zyloprim®

DRUG CLASS

Antigout Agents/Gout Suppressants

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=allopurinol)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Allopurinol | 315-30-0 | C5-H4-N4-O

## CITED REFERENCES

1 Raper R, Ibels L, Lauer C, Barnes P, Lunzer M. Fulminant hepatic failure due to allopurinol. Aust N Z J Med 1984; 14: 63-5.6590011
2 Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7.25754159

## ANNOTATED BIBLIOGRAPHY

References updated: 25 July 2025

Abbreviations: DRESS, drug reaction with eosinophilia and systemic symptoms; SJS, Stevens Johnson Syndrome; TEN, toxic epidermal necrolysis.

Zimmerman HJ. Drugs used to treat gout. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 543-4. (Expert review of allopurinol hepatotoxicity published in 1999; mentions that allopurinol has been implicated in 25 cases of liver injury, usually with fever, rash and eosinophilia arsing 3-6 weeks after starting, sometimes with granulomas on liver biopsy).
Grosser T, Smyth E, FitzGerald GA. Pharmacology of gout. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 702-709. (Textbook of pharmacology and therapeutics).
Hall AP, Holloway VP, Scott JT. 4-hydroxypyrazolo (3,4-d) pyrimidine (HPP) in the treatment of gout: preliminary observations. Ann Rheum Dis 1964; 23: 439-46. (Initial description of allopurinol effects in 4 patients with gout; one developed rash ~6 weeks after starting, resolving on stopping, but not recurring on rechallenge). 14229577
Lidsky MD, Sharp JT. Jaundice with the use of 4-hydroxypyrazolo (3,4-d) pyrimidine. Arthritis Rheum 1967; 10: 294. (Abstract: Among 14 patients with gout given allopurinol, 2 developed cholestatic hepatitis and several more had serum enzyme elevations; preexisting renal disease appeared to be a predisposing factor).
Jarzobski J, Ferry J, Wombolt D, Fitch DM, Egan JD. Vasculitis with allopurinol therapy. Am Heart J 1970; 79: 116-21. (76 year old man developed fever and severe exfoliative rash 4 weeks after starting allopurinol with 9% eosinophils, but normal AST and bilirubin, subsequently developed renal failure and died; autopsy showed hypersensitivity vasculitis involving kidneys, liver, spleen and lungs). 5410273
Kantor GL. Toxic epidermal necrolysis, azotemia, and death after allopurinol therapy. JAMA 1970; 212: 478-9. (72 year old man developed fever and severe rash 2 weeks after starting allopurinol [bilirubin and Alk P not given, ALT 65 U/L, 13% eosinophils, creatinine 3.6 mg/dL], treated with corticosteroids, but died of toxic epidermal necrolysis and sepsis; no mention of liver pathology). 5467301
Mills RM. Severe hypersensitivity reactions associated with allopurinol. JAMA 1971; 216: 799-802. (52 year old man and 59 year old woman developed fever and rash with eosinophilia and renal insufficiency 3 and 5 weeks after starting allopurinol, little documentation of liver involvement, both recovered but required prolonged corticosteroid therapy). 4252397
Simmons F, Feldman B, Gerety D. Granulomatous hepatitis in a patient receiving allopurinol. Gastroenterology 1972; 62: 101-4. (50 year old man developed fever with eosinophilia and enzyme elevations [ALT 320 U/L, Alk P 240 U/L] without jaundice 3 weeks after starting allopurinol; liver biopsy showed granulomas and focal necrosis, rapid resolution with stopping and no granulomas on two follow up biopsies 1 and 4 months later). 5059424
Young JL, Boswell RB, Nies AS. Severe allopurinol hypersensitivity. Association with thiazides and prior renal compromise. Arch Intern Med 1974; 134: 553-8. (40 year old man and 67 year old woman developed fever, rash and eosinophilia 4 weeks after starting allopurinol [bilirubin 2.0 and 1.8 mg/dL, AST 1550 and 210 U/L], one patient dying of liver [bilirubin rising to 15.0 mg/dL] and renal failure, and the other surviving; preexisting renal insufficiency, thiazide use and African-American race were thought to be risk factors). 4546912
McMenamin RA, Davies LM, Craswell PW. Drug induced interstitial nephritis, hepatitis and exfoliative dermatitis. Aust N Z J Med 1976; 6: 583-7. (Among 4 cases of rash, fever, nephritis and hepatitis, one was linked to allopurinol, arising after 6 weeks of therapy [bilirubin 2.5 mg/dL, AST 215 U/L, Alk P 323 U/L, eosinophils 7%], with transient renal failure [creatinine 15 mg/dL], resolving after therapy with prednisone). 139882
Boyer TD, Sun N, Reynolds TB. Allopurinol-hypersensitivity vasculitis and liver damage. West J Med 1977; 126: 143-7. (29, 59 and 67 year old men developed rash and fever 4 weeks after starting allopurinol [bilirubin 14.4, 1.8 and 3.1 mg/dL, ALT 940, 165 and 150 U/L, Alk P 1-3x ULN], 2 had renal insufficiency, 1 case was fatal, and others recovered with prednisone treatment in 1-3 months; rechallenge with a single dose induced fever and rash without liver abnormalities). 139760
Espiritu CR, Alalu J, Glueckauf LG, Lubin J. Allopurinol-induced granulomatous hepatitis. Am J Dig Dis 1976; 21: 804-6. (55 year old woman developed fever and arthralgias [but no rash or eosinophilia] 4 weeks after starting allopurinol [bilirubin 0.9 mg/dL, ALT 140 U/L and Alk P 900 U/L] and biopsy showing granulomas; improved with stopping drug and had normal values and liver histology 3 months later during cholecystectomy). 961676
Chawla SK, Patel HD, Parrino GR, Soterakis J, Lopresti PA, D'Angelo WA. Allopurinol hepatotoxicity. Case report and literature review. Arthritis Rheum 1977; 20: 1546-9. (44 year old man developed abdominal pain a week after starting allopurinol [bilirubin 1.8 mg/dL, AST 50 U/L, Alk P 98 U/L, 8% eosinophils]; biopsy showed noncaseating granulomas; resolved rapidly with stopping therapy). 921828
Butler RC, Shah SM, Grunow WA, Tester EC. Massive hepatic necrosis in a patient receiving allopurinol. JAMA 1977; 237: 473-4. (48 year old woman developed urticaria, fever and rash 1-2 weeks after starting allopurinol [bilirubin 4.6 rising to 13.1 mg/dL, AST 880 U/L, Alk P 188 U/L], and progressive liver failure; autopsy showed massive hepatic necrosis). 576272
Shah SM, Butler RC, Grunow WA, Texter EC Jr. Massive hepatic necrosis in a patient receiving concomitant medication. JAMA 1977; 237: 2036. (Follow up of Butler [1977] listing concomitant medications, none of which were implicated because none had been recently changed). 576881
Swank LA, Chejfec G, Nemchausky BA. Allopurinol-induced granulomatous hepatitis with cholangitis and a sarcoid-like reaction. Arch Intern Med 1978; 138: 997-8. (36 year old man developed fever and polyarthralgias 1 month after starting allopurinol with leukocytosis [bilirubin 4.7 mg/dL, AST 145 U/L, Alk P 875 U/L] and liver biopsy showing multiple noncaseating granulomas and cholangitis, resolved on stopping and follow up liver biopsy was normal). 646570
Male PJ, Schaer B, Posternak R. Reaction d'hypersensibilite a l'allopurinol. Schweiz Med Wochenschr 1978; 108: 661-3. (71 year old man developed fever, rash, eosinophilia and lymphadenopathy 20 days after starting allopurinol [bilirubin 25 mg/dL, ALT "without perturbation", Alk P 252 U/L, abnormal renal function], who was treated with prednisone and recovered).
Medline A, Cohen LB, Tobe BA, Sellers EM. Liver granulomas and allopurinol. Br Med J 1978; 1: 1320-1. (47 year old man on allopurinol for 6 years developed fever and abdominal pain [bilirubin 1.4 mg/dL, ALT 53 U/L, Alk P 3 times ULN, eosinophilia of 7%, ESR 80], who upon cholecystectomy had no stones, but liver biopsy showed multiple noncaseating granulomas and giant cells, resolved on stopping allopurinol and follow up biopsy showed no granulomas). 647256
Korting HC, Lesch R. Acute cholangitis after allopurinol treatment. Lancet 1978; 1: 275-6. (48 year old man with renal insufficiency developed rash, fever and abdominal pain 4-5 weeks after starting allopurinol [bilirubin 1.1 rising to 7.7 mg/dL, ALT 134 U/L, Alk P 1317 U/L, 10% eosinophilia], liver biopsy showing cholangitis and cholestasis, died of multiorgan failure). 74697
Haughey DB, Lanse S, Imhoff T, Tobin M, Schentag JJ. Allopurinol sensitivity: report of two cases. Am J Hosp Pharm 1979; 36: 1377-80. (2 men, ages 72 and 58 years, developed fever, rash and eosinophilia 2 and 4 weeks after starting allopurinol [bilirubin 2.4 and 0.5 mg/dL, AST 510 and 65 U/L, Alk P 198 and 200 U/L], one required prednisone for rash, both recovered). 159623
Lang PG. Severe hypersensitivity reactions to allopurinol. South Med J 1979; 72: 1361-8. (Retrospective analysis of 20 cases of allopurinol hypersensitivity seen at 3 Atlanta hospitals 1973-78; 13 [65%] African-Americans, mean age 59 years, 11 with preexisting renal disease, 5 on thiazides; onset after 1-6 weeks often with rash, which was maculopapular [9], exfoliative [6] or toxic epidermal necrolysis [5]; 6 had liver involvement [bilirubin 1.4-13.8 mg/dL, AST 56-4000 U/L and Alk P 117-450 U/L], 9 had renal involvement, 4 died of complications of skin involvement and sepsis). 159491
Olsen H, Mørland J. Leverskader forårsaket av allopurinol [Hepatic damages caused by allopurinol]. Tidsskr Nor Laegeforen 1980; 100(10): 562-3. Norwegian. (72 year old woman developed evidence of liver injury 3 months after starting allopurinol [ALT 365 U/L, Alk P 599 U/L], resolving within 1.5 weeks of stopping). 7385109
Al-Kawas FH, Seeff LB, Berendson RA, Zimmerman HJ, Ishak KG. Allopurinol hepatotoxicity. Report of two cases and review of literature. Ann Intern Med 1981; 95: 588-90. (Two African-American men developed fever and rash 3 and 4 weeks after starting allopurinol [bilirubin 1.5 and 5.4 mg/dL, ALT 650 and 1780 U/L, Alk P 193 and 248 U/L], recovery within 4-8 weeks of stopping, 1 given prednisone). 7294548
Shah KA, Levin J, Rosen N, Greenwald E, Zumoff B. Allopurinol hepatotoxicity potentiated by tamoxifen. N Y State J Med 1982; 82: 1745-6. (69 year old man on allopurinol for 12 years developed fever and Alk P and LDH elevations 1 day after starting tamoxifen for prostate cancer, fever and enzyme elevations, resolving within 3 days of stopping allopurinol; ALT and AST levels were elevated before tamoxifen therapy and did not change). 6960280
Ramond MJ, Nouel O, Degott C, Lebrec D, Benhamou JP. [Allopurinol-induced hepatitis. Report of a case and review of the literature (author's transl)] Gastroenterol Clin Biol 1982; 6: 138-42. (74 year old woman developed fever and jaundice one month after starting allopurinol with eosinophilia, [bilirubin 5.1 mg/dL, ALT 261 U/L, Alk P 6 times ULN], biopsy showing necrosis, inflammation and granulomas, resolving within 1-2 months of stopping). 7060857
Falco D, Daniels RA, Conklin R. An unusual case of hypersensitivity vasculitis probably due to allopurinol. J Med Soc N J 1982; 79: 409-12. (58 year old African American man with hypertension, congestive heart failure and renal insufficiency developed fatal, progressive vasculitis within days of restarting allopurinol; liver enzymes did not change and there was no eosinophilia). 6954286
Raper R, Ibels L, Lauer C, Barnes P, Lunzer M. Fulminant hepatic failure due to allopurinol. Aust N Z J Med 1984; 14: 63-5. (58 year old Chinese woman developed fever and exfoliative rash 3 weeks after starting allopurinol with eosinophilia, jaundice and fulminant course [bilirubin 12 rising to 30 mg/dL, ALT 1240 U/L, Alk P 1240 U/L]: Case 1). 6590011
Hande KR, Noone RM, Stone WJ. Severe allopurinol toxicity. Description and guidelines for prevention in patients with renal insufficiency. Am J Med 1984; 76: 47-56. (Description of 6 patients with allopurinol toxicity and review of another 72 in the literature [latency 1-8 weeks in 90%, skin rash in 92%, fever 87%, eosinophilia 73%, hepatitis in 68%, renal worsening 85%, death 21%], also mentions that renal insufficiency was a strong risk factor and most patients were estimated to have high allopurinol levels, findings that led to recommendations for modification of dose based upon renal function). 6691361
Ohsawa T, Ohtsubo M. Hepatitis associated with allopurinol. Drug Intell Clin Pharm 1985; 19: 431-3. (66 year old woman developed severe hepatitis 10 days after starting allopurinol [peak bilirubin ~18 mg/dL, ALT 822 U/L, Alk P ~6 times ULN], resolving within 1 month, but recurrence of fever, AST elevation [97 U/L] and eosinophilia [16%] within hours of rechallenge with one dose). 4006738
Mousson C, Justrabo E, Tanter Y, Chalopin JM, Rifle G. [Acute granulomatous interstitial nephritis and hepatitis caused by drugs. Possible role of an allopurinol-furosemide combination] Nephrologie 1986; 7: 199-203. (58 year old woman with renal insufficiency developed fever and rash 6 weeks after starting allopurinol [bilirubin 2.2 mg/dL, ALT 56 U/L, Alk P 780 U/L], and worsening renal function and granulomas in both liver and kidney biopsies). 3822042
Vanderstigel M, Zafrani ES, Lejonc JL, Schaeffer A, Portos JL. Allopurinol hypersensitivity syndrome as a cause of hepatic fibrin-ring granulomas. Gastroenterology 1986; 90: 188-90. (39 year old man developed fever, rash and eosinophilia 4 weeks after starting allopurinol [bilirubin 1.2 mg/dL, ALT 167 U/L, Alk P 406 U/L], biopsy showed granulomas with central vacuole and fibrin ring, infectious causes ruled out). 3940244
Singer JZ, Wallace SL. The allopurinol hypersensitivity syndrome. Unnecessary morbidity and mortality. Arthritis Rheum 1986; 29: 82-7. (Review of 8 cases of allopurinol hypersensitivity in the literature; typically has onset after 2-12 weeks of therapy with fever, rash, eosinophilia and either renal [n=6] or liver [n=6] involvement, 3 died, 7 did not have strong indications for therapy; authors argue against use of allopurinol for asymptomatic hyperuricemia). 3947418
Pewsner D, Bachmann C, Müller U. [Allopurinol-induced kidney failure with hepatitis and squamous dermatitis in pre-existing kidney insufficiency] Schweiz Med Wochenschr 1987; 117: 139-41. (66 year old woman developed rash 6-8 weeks after starting allopurinol with jaundice and worsening renal function [peak bilirubin ~14.7 mg/dL, ALT 297 U/L, Alk P 855 U/L], resolving within 2 months of stopping). 2950589
Olmos M, Guma C, Colombato LO, Lami G, Miyashiro R, Alvarez E. [Hepatic lesions induced by drugs. Report of 26 cases] Acta Gastroenterol Latinoam 1987; 17: 105-11. Spanish. (Review of 2671 liver biopsies done in one Argentinian hospital between 1972-85 identified 26 with drug induced liver disease: 14 from birth control pills, 3 methyldopa, 2 carbon tetrachloride, 2 phenylbutazone, and 1 each from allopurinol [cholestatic hepatitis arising after 90 days], penicillin, chlorpromazine, indomethacin and ketoconazole). 3442185
Stricker BH, Blok AP, Babany G, Benhamou JP. Fibrin ring granulomas and allopurinol. Gastroenterology 1989; 96: 1199-203. (Found 6 cases of granulomas during allopurinol therapy reported to WHO database; onset of fever, rash, arthralgias and eosinophilia within 2-4 weeks of starting drug with biopsies showing ill-defined granuloma-like lesions, but not with fibrin rings). 2925064
González Ramallo VJ, Rodríguez Gorostiza FJ, Muiño Míguez A, López de la Riva M. [Severe cholestasis caused by allopurinol] Rev Esp Enferm Apar Dig 1989; 75: 317-8. Spanish. (74 year old man with mild renal insufficiency developed fever, rash and jaundice 20 days after starting allopurinol [bilirubin 11.1 mg/dL, ALT 107 U/L, Alk P ~3000 U/L]; biopsy showing cholestasis, resolution in 4 weeks of stopping). 2734478
Tam S, Carroll W. Allopurinol hepatotoxicity. Am J Med 1989; 86: 357-8. (Patient on unknown dose of allopurinol for uncertain period developed acute liver failure [initially, bilirubin 1.3 mg/dL, ALT 535 U/L, Alk P 331 U/L], allopurinol levels were ~25-fold elevated suggesting an inadvertent overdose). 2919623
Chong RS, Ng HS, Teh LB, Ho JM. Hepatic granulomas-an experience over the last 8 years. Singapore Med J 1990; 31: 422-6. (Retrospective review identified 20 cases of liver biopsies with granulomas seen over 8 year period, 1 was attributed to allopurinol hypersensitivity: abstract only). 2259936
de Bayser L, Roblot P, Ramassamy A, Silvain C, Levillain P, Becq-Giraudon B. Hepatic fibrin-ring granulomas in giant cell arteritis. Gastroenterology 1993; 105: 272-3. (70 year old man with giant cell arteritis and not on allopurinol had fibrin-ring granulomas in liver with high Alk P, but normal ALT and bilirubin). 8514044
Arellano F, Sacristán JA. Allopurinol hypersensitivity syndrome: a review. Ann Pharmacother 1993; 27: 337-43. (Review of 101 cases of allopurinol hypersensitivity syndrome reported in literature; mean age 57 years, 2/3rds men, fever 95%, rash 93%, leukocytosis 40%, eosinophilia 60%, AST elevation 88%, renal dysfunction common and may play role in pathogenesis). 8453174
Berbegal J, Morera J, Andrada E, Navarro V, Lluch V, López-Benito I. [Syndrome of allopurinol hypersensitivity. Report of a new case and review of the Spanish literature] Med Clin (Barc) 1994; 102: 178-80. Spanish. (75 year old man developed rash and fever 2 weeks after starting allopurinol followed by facial edema and neuropathy with eosinophilia [bilirubin 0.7 mg/dL, ALT 51 U/L, Alk P 494 U/L], liver biopsy showing granulomas, and injury resolving within a few weeks of stopping). 8127168
Roujeau JC. The spectrum of Stevens-Johnson syndrome and toxic epidermal necrolysis: a clinical classification. J Invest Dermatol 1994; 102: 28S-30S. (Consensus of international group of dermatologists on criteria for Stevens Johnson syndrome [SJS] and toxic epidermal necrolysis [TEN] based upon pattern of erythema multiforme-like lesions and extent of dermal detachment). 8006430
Lee SS, Lin HY, Wang SR, Tsai YY. Allopurinol hypersensitivity syndrome. Zhonghua Min Guo Wei Sheng Wu Ji Mian Yi Xue Za Zhi 1994; 27: 140-7.9747344
González U, Reyes E, Kershenovich J, Orozco-Topete RL. [Hypersensitivity syndrome caused by allopurinol. A case of massive hepatic necrosis] Rev Invest Clin 1995; 47: 409-13. Spanish. (Abstract only: 72 year old woman developed fever and Stevens-Johnson syndrome 2 weeks after starting allopurinol, with subsequent fatal renal and hepatic failure). 8584813
Paitel JF, Trechot P, Stockemer V, Dorvaux V, Lederlin P. [Acute liver disease during treatment with pipobroman and allopurinol] Presse Med. 1995; 24: 460. (41 year old woman taking allopurinol for 5 years, developed jaundice 2 months after starting pipobroman for polycythemia vera [bilirubin 11.8 mg/dL, ALT 33 times ULN, normal protime] and recovery in 4-6 months; unlikely due to allopurinol). 7746823
Urban T, Maquarre E, Housset C, Chouaid C, Devin E, Lebeau B. [Allopurinol hypersensitivity. A possible cause of hepatitis and mucocutaneous eruptions in a patient undergoing antitubercular treatment] Rev Mal Respir 1995; 12: 314-6. (39 year old man with tuberculosis developed fever and rash 2 weeks after starting allopurinol; initially with normal liver tests, but then developing lymphadenopathy, eosinophilia [bilirubin normal, ALT 413 U/L, Alk P 143 U/L], resolving rapidly after stopping allopurinol). 7638430
Wade B, Klotz F, Debonne JM, Aubert M. [Fatal hepatitis due to allopurinol in Dakar] Med Trop (Mars) 1995; 55: 186-7.7565008
Andrade RJ, de la Mata M, Lucena MI, López-Rubio F, Corrales MA. [Severe acute hepatitis due to allopurinol in a patient with asymptomatic hyperuricemia and kidney failure. A review of the literature and an analysis of the risk factors] Gastroenterol Hepatol 1997; 20: 353-6. (Patient with mild renal failure developed fever, rash and eosinophilia 19 days after starting allopurinol [bilirubin rising from normal to 27.6 mg/dL, ALT 169 U/L, Alk P 472 U/L, with ascites and prothrombin index 47%], with slow but ultimately complete recovery). 9377233
Jappe U, Franke I, Wendekamm U, Gollnick H. [Allopurinol as an inducer of acute graft-versus-host-like drug reaction. Case report with review of the literature] Hautarzt 1998; 49: 126-30. German. 9551335
Pluim HJ, van Deuren M, Wetzels JFM. The allopurinol hypersensitivity syndrome. Neth J Med 1998; 52: 107-10. (61 year old man developed fever, rash, eosinophilia, facial edema and lymphadenopathy 5 weeks after starting allopurinol, [bilirubin normal, ALT 115 U/L, Alk P 97 U/L] and renal insufficiency requiring high dose prednisolone; slow recovery). 9599967
Kluger E. [Fatal outcome in allopurinol hypersensitivity syndrome] Ugeskr Laeger 1998; 160: 1179-80. Danish. 9492630
Pereira S, Almeida J, Silva AO, Quintas M, Candeias O, Freitas F. [Fatal liver necrosis due to allopurinol] Acta Med Port 1998; 11: 1141-4. Portuguese. 10192993
Khoo BP, Leow YH. A review of inpatients with adverse drug reactions to allopurinol. Singapore Med J 2000; 41: 156-60. (13 patients with adverse reactions to allopurinol over 3 years, all with rash arising after 3-54 [mean=21] days, 10 with fever, 7 had elevated ALT [21-289 U/L], but none had jaundice and all recovered). 11063179
Hammer B, Link A, Wagner A, Böhm M. [Hypersensitivity syndrome during therapy with allopurinol in asymptomatic hyperuricemia with a fatal outcome] Dtsch Med Wochenschr 2001; 126: 1331-4. German. (86 year old woman developed high fever and severe rash progressing to toxic epidermal necrolysis arising 1 week after starting allopurinol for asymptomatic hyperuricemia, liver tests normal, but developed septicemia and multiorgan failure and died). 11719858
Descamps V, Valance A, Edlinger C, Fillet AM, Crossin M, Lerun-Vignes B, Belatch S, et al. Association of human herpesvirus 6 infection with drug reaction with eosinophilia and systemic symptoms. Arch Dermatol 2001; 137: 301-4. (Among 7 patients with drug reaction with eosinophilia and systemic symptoms [DRESS] syndrome, all had anti-HHV-6, 2 in rising titers, 4 with IgM, none had HHV-6 DNA; 5 cases from carbamazepine, 1 sulfasalazine and 1 ibuprofen). 11255328
Vázquez-Mellado J, Morales EM, Pacheco-Tena C, Burgos-Vargas R. Relation between adverse events associated with allopurinol and renal function in patients with gout. Ann Rheum Dis 2001; 60: 981-3. (Among 120 patients with gout treated with allopurinol, adverse events occurred in 5 [rash, hypersensitivity syndrome] including 3 of 52 [6%] receiving a creatinine adjusted dose and 2 of 68 [3%] receiving higher doses). 11557658
Tjwa M, De Hertogh G, Neuville B, Roskams T, Nevens F, Van Steenbergen W. Hepatic fibrin-ring granulomas in granulomatous hepatitis: report of four cases and review of the literature. Acta Clin Belg 2001; 56: 341-8. (4 patients with febrile illnesses were found to have fibrin-ring granulomas on liver biopsy; Q fever in 1, EBV in 1, CMV in 2, one of whom was also receiving allopurinol and thiazides chronically). 11881318
ten Holder SM, Joy MS, Falk RJ. Cutaneous and systemic manifestations of drug-induced vasculitis. Ann Pharmacother 2002; 36: 130-47. (Review of drug induced causes of vasculitis, allopurinol ranking 4th after propylthiouracil, hydralazine and G-CSF; 16 cases reported; 12 men, ages 17-75 with rash, renal, hepatic and other organ involvement; high mortality rate). 11816242
Chan YC, Tay YK, Ng SK. Allopurinol hypersensitivity syndrome and acute myocardial infarction-two case reports. Ann Acad Med Singapore 2002; 31: 231-3. (Two patients with allopurinol hepatotoxicity treated with corticosteroids had myocardial infarctions several months after recovery; authors suggest a link between the two: abstract only). 11957564
Muller P, Dubreil P, Mahé A, Lamaury I, Salzer B, Deloumeaux J, Strobel M. Drug hypersensitivity syndrome in a West-Indian population. Eur J Dermatol 2003; 13: 478-81. (7 year prospective study in Guadeloupe of drug hypersensitivity syndrome; 28 cases found ~1/100,000 incidence, onset averaging 4 weeks, 2 deaths; 7 cases due to allopurinol, frequently given inappropriately, with possible racial predisposition). 14693494
Descamps V, Mahe E, Houhou N, Abramowitz L, Rozenberg F, Ranger-Rogez S, Crickx B. Drug-induced hypersensitivity syndrome associated with Epstein-Barr virus infection. Br J Dermatol 2003; 148: 1032-4. (Patient with rash and fever after 3 weeks of allopurinol with atypical lymphocytosis, eosinophilia, ALT ~250 U/L, Alk P 504 U/L, normal bilirubin and pancreatitis [amylase 1070 U/L], recovery starting 7-10 days after stopping drug; IgM anti-EBV and anti-HHV-6 were present). 12786838
Mete N, Yilmaz F, Gulbahar O, Avdin A, Sin A, Kokuludaq A, Yuce G, Sebik F. Allopurinol hypersensitivity syndrome as a cause of hepatic centrilobular hemorrhagic necrosis. J Investig Allergol Clin Immunol 2003; 13: 281-3. (41 year old developed fever, rash, jaundice and eosinophilia 3 weeks after starting allopurinol with fatal outcome, autopsy showing severe centrolobular necrosis: abstract only). 14989119
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants done in the US between 1990 and 2002, 137 [0.2%] were done for idiosyncratic drug induced acute liver failure, but none were attributed to allopurinol). 15390328
Dia D, Ba-Fall K, Bouldouyre M, Chevalier B, Debonne JM. [DRESS syndrome to allopurinol: a case in Dakar] Dakar Med 2004; 49: 114-5. (47 year old man developed fever, rash and facial edema 3 months after starting allopurinol with eosinophilia and jaundice; rapid resolution with stopping drug: abstract only). 15786619
Russmann S, Lauterburg B. [Life-threatening adverse effects of pharmacologic antihyperuricemic therapy] Ther Umsch 2004; 61: 575-7. (Review of safety of allopurinol and newer xanthine oxidase inhibitors such as febuxostat and benzbromarone). 15493119
Becker MA, Schumacher HR Jr, Wortmann RL, MacDonald PA, Palo WA, Eustace D, Vernillet L, Joseph-Ridge N. Febuxostat compared with allopurinol in patients with hyperuricemia and gout. N Engl J Med 2005; 353: 2450-61. (762 patients at 112 North American centers received either allopurinol [300 mg/day] or febuxostat [80, 120 or 240 mg/day] for 52 weeks; reduction of uric acid to <6 mg/dL achieved in 53-62% of febuxostat- vs 21% of allopurinol-treated patients; rates of acute gout were similar; liver test abnormalities in 4-5% of febuxostat vs 4% of allopurinol recipients; most common cause of discontinuation [2.3%]). 16339094
Gutiérrez-Macías A, Lizarralde-Palacios E, Martínez-Odriozola P, Miguel-De la Villa F. Fatal allopurinol hypersensitivity syndrome after treatment of asymptomatic hyperuricaemia. BMJ 2005; 331: 623-4. (80 year old man developed fever, rash and jaundice with eosinophilia [16%] 6 weeks after starting allopurinol [bilirubin 31.2 mg/dL, ALT 328 U/L, Alk P 6567 U/L], progressing to hepatic failure and death; risk factors were preexisting renal insufficiency and furosemide use). 16166134
Saxena R, Loghmanee F. Fatal drug reaction due to allopurinol therapy in a 72-year-old man. Arch Pathol Lab Med 2005; 129: e183-4. (72 year old man developed fever and severe rash 3 weeks after starting allopurinol, which progressed to generalized blistering and sloughing of skin and death from multiorgan failure). 16048416
Markel A. Allopurinol-induced DRESS syndrome. Isr Med Assoc J 2005; 7: 656-60. (Review of the hypersensitivity reactions to allopurinol including nephro- and hepatotoxicity). 16259349
Hung SI, Chung WH, Liou LB, Chu CC, Lin M, Huang HP, Lin YL, et al. HLA-B*5801 allele as a genetic marker for severe cutaneous adverse reactions caused by allopurinol. Proc Natl Acad Sci U S A 2005; 102: 4134-9. (The HLA-B*58:01 allele was present in all 51 [100%] Chinese patients with allopurinol associated severe cutaneous adverse reactions [SJS/TEN/DRESS], but only 15% of 135 allopurinol tolerant patients and 20% of healthy controls). 15743917
Choi SH, Yang SH, Song YB, Kim HJ, Seo YT, Choi DS, Moon KH, et al. Allopurinol therapy and vanishing bile duct syndrome. Korean J Hepatol 2005; 11: 80-5. (60 year old man developed fever, rash and eosinophilia 1 week after starting allopurinol, with progressive liver failure and death 7 weeks later [bilirubin 1.7 rising to 37.2 mg/dL, ALT 483 to 175 U/L, Alk P 140 to 579U/L], biopsy showing loss of bile ducts). 15788888
Vital Durand D, Durieu I, Rousset H. [Toxic or drug-induced granulomatous reactions] Rev Med Interne 2008; 29: 33-8. French. (Review of drug and toxin induced granulomatous reactions in various organs; in four recent case series, granulomas were found in 292 of 7754 biopsies [4%], of which 2-8% were attributable to drugs, but another 10-30% were "idiopathic" and possibly related; most common agent was allopurinol, but others implicated in single cases were chlorpropamide, phenothiazines, carbamazepine, methyldopa, baclofen, glibencamide, quinidine, metronidazole, and nitrofurantoin). 18054121
Chiou CC, Yang LC, Hung SI, Chang YC, Kuo TT, Ho HC, Hu S, et al. Clinicopathological features and prognosis of drug rash with eosinophilia and systemic symptoms: a study of 30 cases in Taiwan. J Eur Acad Dermatol Venereol 2008; 22: 1044-9. (Over a 5 year period, 30 cases of DRESS syndrome were seen at a single referral center in Taiwan; 15 men and 15 women, ages 13 to 78 years, on drug for 3-60 days [mean=23 days], attributed to allopurinol in 11 [37%], carbamazepine in 6 [20%] and phenytoin, indomethacin and vancomycin in 2 each [7%]; liver test abnormalities in 87%, jaundice in 17% and 3 died [10%], but none of liver failure). 18627428
Halevy S, Ghislain PD, Mockenhaupt M, Fagot JP, Bouwes Bavinck JN, Sidoroff A, Naldi L, et al.; EuroSCAR Study Group. Allopurinol is the most common cause of Stevens-Johnson syndrome and toxic epidermal necrolysis in Europe and Israel. J Am Acad Dermatol 2008; 58: 25-32. (Among 379 patients with SJS/TEN, allopurinol was the most frequent cause [n=66: 17%], which was taken by only 2% of matched controls without severe cutaneous adverse events). 17919772
Kaniwa N, Saito Y, Aihara M, Matsunaga K, Tohkin M, Kurose K, Sawada J, et al; JSAR research group. HLA-B locus in Japanese patients with anti-epileptics and allopurinol-related Stevens-Johnson syndrome and toxic epidermal necrolysis. Pharmacogenomics 2008; 9: 1617-22. (Among 58 Japanese patients with SJS/TEN, none of 7 carbamazepine attributed cases had B*15:02, and only 4 of 10 allopurinol cases had B*58:01, the allele frequency being 20% in cases vs 0.6% in the population). 19018717
Schumacher HR Jr, Becker MA, Wortmann RL, MacDonald PA, Hunt B, Streit J, Lademacher C, Joseph-Ridge N. Effects of febuxostat versus allopurinol and placebo in reducing serum urate in subjects with hyperuricemia and gout: a 28-week, phase III, randomized, double-blind, parallel-group trial. Arthritis Rheum 2008; 59: 1540-8. (Among 1072 patients with gout randomized to different treatments for 28 weeks, abnormal liver tests [=1.5 times ULN] occurred in 4-6% on febuxostat, 2% placebo, and 6% allopurinol). 18975369
Shalom R, Rimbroth S, Rozenman D, Markel A. Allopurinol-induced recurrent DRESS syndrome: pathophysiology and treatment. Ren Fail 2008; 30: 327-9. (65 year old man with mild renal insufficiency developed rash and fever, 1 week after starting allopurinol with eosinophilia [bilirubin 1.0 mg/dL, ALT 76 U/L] and responding to prednisone, but relapsing twice when prednisone was stopped with fever, rash, eosinophilia and more severe liver abnormalities [bilirubin 1.9 mg/dL, ALT 1784 U/L]). 18350453
Khanlari B, Bodmer M, Terracciano L, Heim MH, Fluckiger U, Weisser M. Hepatitis with fibrin-ring granulomas. Infection 2008; 36: 381-3. (66 year old woman developed fever and jaundice 4 months after starting allopurinol [bilirubin 1.2 mg/dL, ALT 89 U/L, Alk P 236 U/L] and ring granulomas on liver biopsy; corticosteroids led to worsening and repeat biopsy showed Leishmania: Kala-azar). 17926000
Yoon JY, Min SY, Park JY, Hong SG, Park SJ, Paik SY, Park YM. [A case of allopurinol-induced granulomatous hepatitis with ductopenia and cholestasis] Korean J Hepatol 2008; 14: 97-101. (69 year old man with renal failure developed rash and fever 2 weeks after starting allopurinol, liver biopsy showing spotty necrosis, cholestasis, ductopenia and granulomas, recovery with corticosteroids: abstract only). 18367862
Lonjou C, Borot N, Sekula P, Ledger N, Thomas L, Halevy S, Naldi L, et al.; RegiSCAR study group. A European study of HLA-B in Stevens-Johnson syndrome and toxic epidermal necrolysis related to five high-risk drugs. Pharmacogenet Genomics 2008; 18: 99-107. (HLA-B genotyping of a cohort of patients with Stevens Johnson syndrome [SJS] due to medications found an association of B*58:01 with SJS due to allopurinol in 4 non-Europeans [100%] as well as 27 Europeans [55%] compared to controls [1.5%] and a slight association of B*3801 with SJS due to lamotrigine [24%] and sulfonamides [28%] compared to controls [4.3%]). 18192896
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, two were attributed to allopurinol). 18955056
Tausche AK, Aringer M, Schroeder HE, Bornstein SR, Wunderlich C, Wozel G. The Janus faces of allopurinol-allopurinol hypersensitivity syndrome. Am J Med 2008; 121: e3-4. (69 year old woman developed rash 3 months after starting allopurinol [bilirubin not given, ALT 10 fold elevated], resolving with corticosteroid therapy). 18328291
Eshki M, Allanore L, Musette P, Milpied B, Grange A, Guillaume JC, Chosidow O, et al. Twelve-year analysis of severe cases of drug reaction with eosinophilia and systemic symptoms: a cause of unpredictable multiorgan failure. Arch Dermatol 2009; 145: 67-72. (Retrospective analysis of 15 patients with severe drug rash with eosinophilia and systemic symptoms [DRESS] syndrome from France; 2/3rds women, ages 15-71, onset average of 18 days, 4 due to allopurinol; severe manifestations including hepatitis [n=7], pneumonitis [10], renal failure [5], encephalitis [2], pancytopenia [2], heart failure [1]). 19153346
Tassaneeyakul W, Jantararoungtong T, Chen P, Lin PY, Tiamkao S, Khunarkornsiri U, Chucherd P, et al. Strong association between HLA-B*5801 and allopurinol-induced Stevens-Johnson syndrome and toxic epidermal necrolysis in a Thai population. Pharmacogenet Genomics 2009; 19: 704-9. (Among 27 Thai patients with SJS/TEN due to allopurinol, all had HLA-B*58:01 compared to 7 of 54 [13%] allopurinol tolerant controls). 19696695
Lindh J. [Hepatic adverse effects of allopurinol]. Lakartidningen 2009; 106: 2374-5. Swedish. (Commentary on response to ALT elevations occurring during allopurinol therapy mentions that the acute liver injury occurs in 0.2-0.4% of patients, typically in the first 2 months and with prominent immunoallergic features). 19848345
Gyotoku E, Iwamoto T, Ochi M. [A fatal case of drug-induced hypersensitivity syndrome due to allopurinol]. Arerugi 2009; 58: 560-6. Japanese. (83 year old woman developed fever and disseminated rash 1 month after starting allopurinol with progressive liver failure and death: abstract only). 19487838
Um SJ, Lee SK, Kim YH, Kim KH, Son CH, Roh MS, Lee MK. Clinical features of drug-induced hypersensitivity syndrome in 38 patients. J Investig Allergol Clin Immunol 2010; 20: 556-62. (Among 38 patients with DRESS seen at a single referral center in Korea over a 5 year period, 20 were women, ages 24 to 80 years, onset after 3-105 days, all had liver involvement; 8 due to carbamazepine, 4 phenytoin, 3 lamotrigine, 2 phenobarbital and 2 allopurinol; 1 death from liver failure). 21313995
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, one of which was attributed to allopurinol). 20949552
Chen YC, Chiu HC, Chu CY. Drug reaction with eosinophilia and systemic symptoms: a retrospective study of 60 cases. Arch Dermatol 2010; 146: 1373-9. (Among 60 cases of DRESS syndrome seen at a referral center in Taiwan over a 10 year period, the most common causes were allopurinol [31%], phenytoin [18%] and dapsone [17%]; 80% had hepatic manifestations; mean onset of allopurinol cases was 27 days, which was longer than for phenytoin [14 days] and others [19 days]). 20713773
Somkrua R, Eickman EE, Saokaew S, Lohitnavy M, Chaiyakunapruk N. Association of HLA-B*5801 allele and allopurinol-induced Stevens Johnson syndrome and toxic epidermal necrolysis: a systematic review and meta-analysis. BMC Med Genet 2011; 12: 118. (Systematic review of evidence linking HLA-B*58:01 to allopurinol associated Stevens Johnson syndrome [SJS] and toxic epidermal necrosis [TEN], in 4 studies with matched controls, 54 of 55 cases [98%], but only 74 of 678 controls [11%] had the HLA allele whereas in 5 studies using population control, the carrier frequency was 50 of 69 cases [72%] vs 171 of 3378 controls [5%]; the analysis combined European and Asian studies). 21906289
Kang HR, Jee YK, Kim YS, Lee CH, Jung JW, Kim SH, Park HW, et al; Adverse Drug Reaction Research Group in Korea. Positive and negative associations of HLA class I alleles with allopurinol-induced SCARs in Koreans. Pharmacogenet Genomics 2011; 21: 303-7. (Among 25 Korean patients with severe cutaneous adverse reactions to allopurinol, all except two [92%] had HLA-B*58:01 compared to 10.5% of 57 tolerant Korean patients). 21301380
Génin E, Schumacher M, Roujeau JC, Naldi L, Liss Y, Kazma R, Sekula P, et al. Genome-wide association study of Stevens-Johnson Syndrome and Toxic Epidermal Necrolysis in Europe. Orphanet J Rare Dis 2011; 6: 52. (Genome wide association study on 424 cases of SJS/TEN from Europe identified 6 SNPs in the HLA region as being significant; best association being HLA-B*58:01 in 57 patients with allopurinol associated hypersensitivity). 21801394
Cacoub P, Musette P, Descamps V, Meyer O, Speirs C, Finzi L, Roujeau JC. The DRESS syndrome: a literature review. Am J Med 2011; 124: 588-97. (Systematic review of literature on DRESS identified 172 cases due to 44 drugs, most frequently carbamazepine [27%] and allopurinol [11%], similar sex distribution, ages 0.5 to 80 years, onset after 0.5-16 weeks [mean=3.9], liver involvement 94%, eosinophilia 64%, mortality 5%). 21592453
Natkunarajah J, Goolamali S, Craythorne E, Benton E, Smith C, Morris-Jones R, Wendon J, et al. Ten cases of drug reaction with eosinophilia and systemic symptoms (DRESS) treated with pulsed intravenous methylprednisolone. Eur J Dermatol 2011; 21: 385-91. (Prospective study on use of methylprednisolone in 10 patients with DRESS, found rapid improvement in all but one who required a liver transplant). 21527371
Jung JW, Song WJ, Kim YS, Joo KW, Lee KW, Kim SH, Park HW, et al. HLA-B58 can help the clinical decision on starting allopurinol in patients with chronic renal insufficiency. Nephrol Dial Transplant 2011; 26: 3567-72. (Among 448 Korean patients with chronic renal dysfunction treated with allopurinol, 16 [3.6%] had a cutaneous adverse reaction, including 2 with SJS, 7 with allopurinol hypersensitivity syndrome [AHS] and 7 with maculopapular rash without systemic signs; HLA-B*58:01 was found in all 9 patients with SJS or AHS but in none with rash only and in only 9.5% who were tolerant to allopurinol). 21393610
Lee MH, Stocker SL, Anderson J, Phillips EJ, Nolan D, Williams KM, Graham GG, et al. Initiating allopurinol therapy: do we need to know the patient's human leucocyte antigen status? Intern Med J 2012; 42: 411-6. (HLA-B*58:01 was present in all 4 Asian patients with SJS due to allopurinol, but in only 2 of 8 Caucasians with SJS/hypersensitivity syndrome and in 0 of 12 with rash alone due to allopurinol). 21790926
Tan SK, Tay YK. Profile and pattern of Stevens-Johnson syndrome and toxic epidermal necrolysis in a general hospital in Singapore: treatment outcomes. Acta Derm Venereol 2012; 92: 62-6. (Among 28 cases of SJS/TEN seen at a single referral hospital in Singapore between 2004-2010, 26 were attributed to drugs, but only 2 were due to allopurinol). 21710108
Pirmohamed M. Genetics and the potential for predictive tests in adverse drug reactions. Chem Immunol Allergy 2012; 97: 18-31. (Brief review of the association of HLA alleles with cutaneous adverse events, focusing upon skin reactions to allopurinol, carbamazepine and abacavir and hepatotoxicity associated with flucloxacillin, lumiracoxib, lapatinib and ximelagatran). 22613851
Yun J, Adam J, Yerly D, Pichler WJ. Human leukocyte antigens (HLA) associated drug hypersensitivity: consequences of drug binding to HLA. Allergy 2012; 67: 1338-46. (Review of current understanding of the pathogenesis of the association of specific HLA alleles with drug induced hypersensitivity reactions, focusing upon abacavir, carbamazepine and allopurinol). 22943588
Biagioni E, Busani S, Rinaldi L, Marietta M, Girardis M. Acute renal failure and liver necrosis associated to allopurinol therapy. Anaesth Intensive Care 2012; 40: 190-1.22313089
Botelho LF, Higashi VS, Padilha MH, Enokihara MM, Porro AM. DRESS: clinicopathological features of 10 cases from an University Hospital in São Paulo. An Bras Dermatol 2012; 87: 703-7. (Among 10 patients with DRESS syndrome seen at a referral hospital in Brazil between 2005-2011, 6 were in men, ages 20 to 66 years, and onset occurred within 2-6 weeks of starting; phenytoin in 4, allopurinol in 2, or carbamazepine, diclofenac, or both in 1 each; 2 died of acute liver failure). 23044561
Yaylacı S, Demir MV, Temiz T, Tamer A, Uslan MI. Allopurinol-induced DRESS syndrome. Indian J Pharmacol 2012; 44: 412-4. (70 year old Turkish man with hypertension and renal disease developed fever, rash and jaundice 3 months after starting allopurinol [bilirubin 18.9 mg/dL, ALT 429 U/L, Alk P 773 U/L, INR 1.4], with progressive renal and liver failure and death within 24 days of onset). 22701258
Cao ZH, Wei ZY, Zhu QY, Zhang JY, Yang L, Qin SY, Shao LY, et al. HLA-B*58:01 allele is associated with augmented risk for both mild and severe cutaneous adverse reactions induced by allopurinol in Han Chinese. Pharmacogenomics 2012; 13: 1193-201. (Among 38 Chinese patients with severe cutaneous reactions from allopurinol, all had HLA-B*58:01 [5 were homozygous] compared to 11% of matched controls [none of whom were homozygous] and 14% of population controls). 22909208
Stamp LK, Taylor WJ, Jones PB, Dockerty JL, Drake J, Frampton C, Dalbeth N. Starting dose is a risk factor for allopurinol hypersensitivity syndrome: a proposed safe starting dose of allopurinol. Arthritis Rheum 2012; 64: 2529-36. (Among 54 cases of allopurinol hypersensitivity syndrome identified over a 12 year period in New Zealand, 56% were men, ages 24 to 87 years, mean onset in 30 days, 3 were fatal [6%]; compared to controls, cases were more likely to start at a higher dose when corrected for creatinine). 22488501
Chiu ML, Hu M, Ng MH, Yeung CK, Chan JC, Chang MM, Cheng SH, Li L, Tomlinson B. Association between HLA-B*58:01 allele and severe cutaneous adverse reactions with allopurinol in Han Chinese in Hong Kong. Br J Dermatol 2012; 167: 44-9. (Among 20 Chinese patients from Hong Kong with severe cutaneous reactions to allopurinol, 19 [95%] had HLA B*58:01 compared to 13% of 30 allopurinol tolerant controls). 22348415
Maekawa K, Nishikawa J, Kaniwa N, Sugiyama E, Koizumi T, Kurose K, Tohkin M, et al. Development of a rapid and inexpensive assay for detecting a surrogate genetic polymorphism of HLA-B*58:01: a partially predictive but useful biomarker for allopurinol-related Stevens-Johnson syndrome/toxic epidermal necrolysis in Japanese. Drug Metab Pharmacokinet 2012; 27: 447-50. (Description of a polymerase chain reaction based assay specifically designed to detect HLA-B*58:01 polymorphisms). 22277675
Profaizer T, Eckels D. HLA alleles and drug hypersensitivity reactions. Int J Immunogenet 2012; 39: 99-105. (Review of the HLA associations of drug hypersensitivity reactions to abacavir, allopurinol and carbamazepine). 22136512
Bharadwaj M, Illing P, Theodossis A, Purcell AW, Rossjohn J, McCluskey J. Drug hypersensitivity and human leukocyte antigens of the major histocompatibility complex. Annu Rev Pharmacol Toxicol 2012; 52: 401-31. (Review of the molecular pathogenesis of T cell mediated hypersensitivity reactions to small molecule drugs, focusing upon class I HLA B*57:01 associations with abacavir and flucloxacillin], B*58:01 with allopurinol, and B*15:02 with carbamazepine and possibly phenytoin; and type II HLA associations with lapatinib and ximelagatran). 22017685
Wongkitisophon P, Chanprapaph K, Rattanakaemakorn P, Vachiramon V. Six-year retrospective review of drug reaction with eosinophilia and systemic symptoms. Acta Derm Venereol 2012; 92: 200-5. (Among 27 patients with DRESS syndrome seen at a single center in Thailand, 14 were men and ages ranged from 23 to 81 years; 96% of cases had hepatic manifestations, 70% eosinophilia, 19% atypical lymphocytosis; common causes were phenytoin [33%] allopurinol [15%], nevirapine [15%]; liver injury resolved in 20-65 days except in 1 patient who died [4%]). 22002792
Bollaert M, Jeulin H, Waton J, Gastin I, Tréchot P, Rabaud C, Schmutz JL, Barbaud A. [Six cases of spring DRESS]. Ann Dermatol Venereol 2012; 139: 15-22. (Six cases of DRESS syndrome presented at a single hospital during a one month period, suggesting an epidemic, although each case was due to a different drug [allopurinol, carbamazepine, amoxicillin, TMP/SMZ, and others], and all had evidence of reactivation or primary infection with a herpes virus). 22225738
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, Presentation and Outcomes in Patients with Drug-Induced Liver Injury in the General Population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to allopurinol). 23419359
Kardaun SH, Sekula P, Valeyrie-Allanore L, Liss Y, Chu CY, Creamer D, Sidoroff A, et al; The RegiSCAR study group. Drug Reaction with Eosinophilia and Systemic Symptoms (DRESS): an original multisystem adverse drug reaction. Results from the prospective RegiSCAR study. Br J Dermatol 2013; 169: 1071-80. (Among 117 cases of DRESS enrolled in a European prospective database over a 6 year period, 18% were due to allopurinol, 75% had liver involvement and only 2 died [2%]). 23855313
Paisansinsup T, Breitenstein MK, Schousboe JT. Association between adverse reactions to allopurinol and exposures to high maintenance doses: implications for management of patients using allopurinol. J Clin Rheumatol 2013; 19: 180-6. (Analysis of electronic medical records of a multispecialty group practice between 2004-2011 identified 2946 patients who were treated with allopurinol and had a serum creatinine level; 48 [2%] had an adverse drug reaction [mostly rash] and 2 had SJS; no association was found between these reactions and allopurinol dose even after adjustment for renal function). 23669799
Ramasamy SN, Korb-Wells CS, Kannangara DR, Smith MW, Wang N, Roberts DM, Graham GG, et al. Allopurinol hypersensitivity: a systematic review of all published cases, 1950-2012. Drug Saf 2013; 36: 953-80. (Systematic review of literature on allopurinol hypersensitivity syndrome identified 901 patients in 320 publications, including 58% men, 73% Asians, median onset in 3 weeks, mortality rate 14%; among those with liver involvement, mean bilirubin 6.4 mg/dL, ALT 358 U/L, Alk P 518 U/L; 166 of 167 Asian patients tested were HLA-B*58:01 positive). 23873481
Kwok J, Kwong KM. Detection of HLA-B*58:01, the susceptible allele for allopurinol-induced hypersensitivity, by loop-mediated isothermal amplification. Br J Dermatol 2013; 168: 526-32. (Description of development of a loop mediated isothermal amplification method for identifying DNA of HLA-B*58:01 that can be used clinically and is faster and easier than standard genotyping methods). 23066948
Kim SC, Newcomb C, Margolis D, Roy J, Hennessy S. Severe cutaneous reactions requiring hospitalization in allopurinol initiators: a population-based cohort study. Arthritis Care Res (Hoboken) 2013; 65: 578-84. (Using electronic records of 5 large Medicaid programs of approximately 13 million enrollees, 90,358 patients were started on allopurinol and were followed, among whom 45 were subsequently hospitalized for a severe cutaneous reaction [0.69 per 1000 patient years] and 12 died; rates that were far higher than in non-allopurinol users [0.04 per 1000 patient years). 22899369
Ryu HJ, Song R, Kim HW, Kim JH, Lee EY, Lee YJ, Song YW, Lee EB. Clinical risk factors for adverse events in allopurinol users. J Clin Pharmacol 2013; 53: 211-6. (Case control study of 94 patients with adverse event [rash, GI upset, hypersensitivity syndrome, severe, neuropathy] due to allopurinol and 378 tolerant controls found risk factors to be renal disease and use of colchicine or statins). 23436266
Lee MH, Stocker SL, Williams KM, Day RO. HLA-B*5801 should be used to screen for risk of Stevens-Johnson syndrome in family members of Han Chinese patients commencing allopurinol therapy. J Rheumatol 2013; 40: 96-7. (Letter describing Chinese man who developed SJS after allopurinol exposure and tested positive for HLA-B*58:01 who had a brother who tolerated allopurinol, but was B*58:01 negative). 23280169
Walsh S, Diaz-Cano S, Higgins E, Morris-Jones R, Bashir S, Bernal W, Creamer D. Drug reaction with eosinophilia and systemic symptoms: is cutaneous phenotype a prognostic marker for outcome? A review of clinicopathological features of 27 cases. Br J Dermatol 2013; 168: 391-401. (Among 27 patients with DRESS presenting at a single UK referral center over a 6 year period, 2 [7%] were due to allopurinol, 6 phenytoin, 5 carbamazepine; the mortality rate was 11% and severe cases were more likely to have erythema multiforme like lesions by histology). 23034060
Choi HG, Byun J, Moon CH, Yoon JH, Yang KY, Park SC, Han CJ. Allopurinol-induced DRESS syndrome mimicking biliary obstruction. Clin Mol Hepatol 2014; 20: 71-5. (84 year old man developed fever, rash and jaundice 2 months after starting allopurinol [bilirubin 6.6 rising to 27.1 mg/dL, ALT 343 U/L, Alk P 210 U/L, eosinophils 14%], with progressive worsening and sudden death from a myocardial infarction). 24757661
Sultan SJ, Sameem F, Ashraf M. Drug reaction with eosinophilia and systemic symptoms: manifestations, treatment, and outcome in 17 patients. Int J Dermatol 2015; 54 (5): 537-42. (Among 17 patients with DRESS syndrome seen at a single medical center in India over a 4 year period, causes were anticonvulsants [65%], dapsone, vancomycin, leflunomide, nitrofurantoin and allopurinol). 24738653
Daly AK. Human leukocyte antigen (HLA) pharmacogenomic tests: potential and pitfalls. Curr Drug Metab 2014; 15: 196-201. (Discussion of the shortcomings of use of HLA associations in clinical decisions to use drugs associated with severe hypersensitivity reactions including allopurinol). 24694233
Karlin E, Phillips E. Genotyping for severe drug hypersensitivity. Curr Allergy Asthma Rep 2014; 14: 418. (Review of the genetic associations and potential clinical applications of genotyping to prevent serious drug adverse reactions, including testing for HLA-B*58:01 to assess the risk of SJS from allopurinol, particularly in Asian populations). 24429903
Thankachen J, Agarwal V. Challenges in diagnosis, management, and treatment of allopurinol-induced DRESS syndrome: case report and literature review. Am J Ther 2015; 22 (3): e77-83. (62 year old African American woman developed fever, rash and confusion 3 weeks after a 2 day course of allopurinol [bilirubin not given, ALT 116 U/L, Alk P 198 U/L, eosinophils 16%], rash considered typical of DRESS, responding to corticosteroids, and resolving within 3 months of onset). 24451301
Nam YH, Park MR, Nam HJ, Lee SK, Kim KH, Roh MS, Um SJ, Son CH. Drug reaction with eosinophilia and systemic symptoms syndrome is not uncommon and shows better clinical outcome than generally recognised. Allergol Immunopathol (Madr) 2015; 43 (1):19-24. (Among 45 patients with DRESS seen over a 2 year period at a single Korean referral center, all had fever, rash and eosinophilia, 87% had liver involvement and 1 died of liver failure and 1 of sepsis; common causes included cephalosporins [29%], penicillins [9%], anticonvulsants [27%], NSAIDs [9%] and allopurinol [7%]). 24388810
Yang MS, Kang MG, Jung JW, Song WJ, Kang HR, Cho SH, Min KU. Clinical features and prognostic factors in severe cutaneous drug reactions. Int Arch Allergy Immunol 2013; 162: 346-54. (Allopurinol accounted for 17% of 41 cases of SJS/TEN and 31% of cases of DRESS syndrome; ALT elevations occurred in 46% of SJS/TEN and 75% of DRESS cases). 24193402
Lee T, Lee YS, Yoon SY, Kim S, Bae YJ, Kwon HS, Cho YS, et al. Characteristics of liver injury in drug-induced systemic hypersensitivity reactions. J Am Acad Dermatol 2013; 69: 407-15. (Among 136 Korean patients with drug hypersensitivity reactions, 61 had liver dysfunction, 29 with DRESS and 11 with SJS/TEN, and allopurinol was the most common cause in SJS/TEN cases). 23632341
Gonçalo M, Coutinho I, Teixeira V, Gameiro AR, Brites MM, Nunes R, Martinho A. HLA-B*58:01 is a risk factor for allopurinol-induced DRESS and Stevens-Johnson syndrome/toxic epidermal necrolysis in a Portuguese population. Br J Dermatol 2013; 169: 660-5. (Among 6 Portuguese patients with SJS/TEN and 19 with DRESS due to allopurinol, HLA-B*58:01 was present in 16 [64%] compared to 4% of 28 allopurinol tolerant persons and 2% of normal controls; rates similar to those reported in other European populations). 23600531
Fernando SL. Drug-reaction eosinophilia and systemic symptoms and drug-induced hypersensitivity syndrome. Australas J Dermatol 2014; 55: 15-23. (Review of the definition, epidemiology, causes, clinical features, pathology, pathogenesis and management of DRESS syndrome; allopurinol being the second most common cause). 23866082
Limpawattana P, Choonhakarn C, Kongbunkiat K. Clinical profiles of Stevens-Johnson syndrome among Thai patients. J Dermatol 2014; 41(7): 634-7. (Among 45 patients with SJS seen at a single referral center in Thailand over a 10 year period, liver injury occurred in 67%, but was usually mild and allopurinol accounted for 13% of cases, including 6 of 13 cases in patients over the age of 65). 24815085
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to allopurinol). 24552865
Miederer SE, Miederer KO. [Allopurinol hypersensitivity syndrome: Liver transplantation after treatment of asymptomatic hyperuricaemia]. Dtsch Med Wochenschr 2014; 139: 2537-40. (41 year old man developed fever, rash and liver test abnormalities 1 month after starting allopurinol [bilirubin rising to 54 mg/dL, ALT 548 U/L, Alk P 1268 U/L], and undergoing successful liver transplantation). 25423467
Jung JW, Kim DK, Park HW, Oh KH, Joo KW, Kim YS, Ahn C, Leet al. An effective strategy to prevent allopurinol-induced hypersensitivity by HLA typing. Genet Med 2015; 17: 807-14. (Among 401 Korean patients with renal disease planning to start allopurinol, 46 had HLA-B*58:01 and received a tolerance induction protocol [n=30] or another medication [n=16], and none developed serious cutaneous reactions, nor did any of the 355 who tested negative for this HLA allele). 25634024
Ko TM, Tsai CY, Chen SY, Chen KS, Yu KH, Chu CS, Huang CM, et al; Taiwan Allopurinol-SCAR Consortium. Use of HLA-B*58:01 genotyping to prevent allopurinol induced severe cutaneous adverse reactions in Taiwan: national prospective cohort study. BMJ 2015; 351: h4848. (Among 2926 Taiwanese patients planning to start allopurinol, 571 had HLA-B*58:01 and were advised not to take it, of whom none developed rash; among the 2173 without this HLA allele who took allopurinol, 97 [3%] had mild rash, but none had a severe cutaneous reaction). 26399967
Yip VL, Alfirevic A, Pirmohamed M. Genetics of immune-mediated adverse drug reactions: a comprehensive and clinical review. Clin Rev Allergy Immunol 2015; 48: 165-75. (Review of the genetics of immune mediated drug reactions focusing upon skin injury from abacavir [HLA-B*57:01], carbamazepine [B*15:02, A*31:01], and allopurinol [B*58:01] and hepatotoxicity from amoxicillin/ clavulanate [several], flucloxacillin [B*57:01], ximelagatran, lumiracoxib, lapatinib, ticlopidine and nevirapine). 24777842
Imai H, Kamei H, Onishi Y, Yamada K, Ishizu Y, Ishigami M, Goto H, Ogura Y. Successful living-donor liver transplantation for cholestatic liver failure induced by allopurinol: case report. Transplant Proc 2015; 47: 2778-81. (39 year old Japanese man developed severe cholestatic liver injury 2 months after starting allopurinol for hyperuricemia [bilirubin rising to 60.9 mg/dL, INR 3.5], undergoing successful living donor liver transplantation 4 months later). 26680093
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 7 cases [0.9%] were attributed to allopurinol, 3 of which were severe and one fatal). 25754159
Sultan SJ, Sameem F, Ashraf M. Drug reaction with eosinophilia and systemic symptoms: manifestations, treatment, and outcome in 17 patients. Int J Dermatol 2015; 54: 537-42. (Among 17 patients with DRESS syndrome seen at a referral center in India over a 4 year period, most cases [65%] were due to aromatic anticonvulsants, 2 to allopurinol and 1 each for vancomycin, leflunomide, dapsone and nitrofurantoin, with ALT elevations above 100 U/L in all 17, hyperbilirubinemia in 65% and liver failure in one). 24738653
Park HJ, Kim SR, Leem DW, Moon IJ, Koh BS, Park KH, Park JW, et al. Clinical features of and genetic predisposition to drug-induced Stevens-Johnson syndrome and toxic epidermal necrolysis in a single Korean tertiary institution patients-investigating the relation between the HLA -B*4403 allele and lamotrigine. Eur J Clin Pharmacol 2015; 71: 35-41. (Among 30 patients with SJS/TEN seen at a single Korean medical center between 2010 and 2014, 63% had accompanying liver injury and 2 died; allopurinol was the single most common cause [n=7: 27%], 5 cases of which had HLA-B*58:01 vs 1 of the 23 others, mean latency was 20 days). 25327504
Civardi G, Zanlari L, Bassi E, Zangrandi A, Maria Cesinaro A, Nosseir S, De Maria N. Life threatening, allopurinol-related Dress syndrome as a rare cause of fever of unknown origin. Intern Med 2015; 54: 2073-7. (38 year old woman developed fever, rash and eosinophilia 2-3 weeks after starting allopurinol for hyperuricemia, followed by severe liver and renal dysfunction but with ultimate full recovery). 26278306
Polimeni G, Cardillo R, Garaffo E, Giardina C, Macrì R, Sirna V, Guarneri C, Arcoraci V. Allopurinol-induced Sweet's syndrome. Int J Immunopathol Pharmacol 2016; 29: 329-32. (87 year old woman developed “Sweet’s” syndrome 8 days after starting allopurinol for hyperuricemia [6.2 mg/dL] with fever, rash, pus-filled skin blisters, conjunctivitis, joint pains and leukocytosis [bilirubin 1.3 mg/dL, ALT and Alk P not provided, GGT “doubling”], responding to stopping allopurinol and systemic corticosteroids). 26684631
Hiransuthikul A, Rattananupong T, Klaewsongkram J, Rerknimitr P, Pongprutthipan M, Ruxrungtham K. Drug-induced hypersensitivity syndrome/drug reaction with eosinophilia and systemic symptoms (DIHS/DRESS): 11 years retrospective study in Thailand. Allergol Int 2016; 65: 432-8. (Among 52 patients with DRESS syndrome seen at a referral hospital in Thailand between 2004 and 2014, 12 cases were due to phenytoin, 9 nevirapine, 8 allopurinol and 7 amoxicillin/clavulanate; the allopurinol cases had a mean age of 75 years, latency 30 days, 88% with eosinophilia, 100% with liver and 63% with kidney involvement, no deaths but 58% received systemic corticosteroids). 27134114
Pinto Gouveia M, Gameiro A, Coutinho I, Pereira N, Cardoso JC, Gonçalo M. Overlap between maculopapular exanthema and drug reaction with eosinophilia and systemic symptoms among cutaneous adverse drug reactions in a dermatology ward. Br J Dermatol 2016; 175: 1274-83. (Among 132 patients with cutaneous adverse drug reactions admitted to a dermatology ward in a Portuguese referral center between 2010 and 2015, 37 met criteria for DRESS syndrome whereas 28 had a maculopapular exanthem, 7 had SJS and 55 other dermatoses; allopurinol was the most frequent cause of DRESS [n=15: 40%], and both eosinophilia and liver involvement were frequent [both 78%] and among allopurinol cases, HLA-B*58:01 was present in 7 of 11 [64%] with DRESS and 2 of 5 [40%] with other maculopapular exanthema). 27128886
Stamp LK, Chapman PT, Barclay ML, Horne A, Frampton C, Tan P, Drake J, et al. A randomised controlled trial of the efficacy and safety of allopurinol dose escalation to achieve target serum urate in people with gout. Ann Rheum Dis 2017; 76: 1522-8. (Among 183 patients with gout on allopurinol but with serum uric acid levels above 6 mg/dL who were either maintained on the same dose or had dose increases, serum uric acid levels decreased more with higher doses, but there were no differences in flares of gout, and side effects of pruritus and rash and GGT elevations were more frequent with dose escalation but no patient developed clinically apparent liver injury). 28314755
Waseem H, Inayat F, Abduraimova M, Kamholz S. Allopurinol-induced drug reaction with eosinophilia and systemic symptoms syndrome: a cause of acalculous cholecystitis? Cureus 2017; 9: e1569. (71 year old Chinese woman developed rash and fever within days of starting allopurinol with two recurrences after restarting for 1-2 days [eosinophils 17%, bilirubin 2.2 mg/dL, ALT 56 U/L, Alk P 100] thought to also have acalculous cholecystitis, rash and fever responding rapidly to systemic corticosteroids). 29057181
Iqbal U, Siddiqui HU, Anwar H, Chaudhary A, Quadri AA. Allopurinol-induced granulomatous hepatitis: a case report and review of literature. J Investig Med High Impact Case Rep 2017; 5: 2324709617728302. (83 year old man was found to have abnormal liver tests having been taking allopurinol, losartan and statins for years [bilirubin 0.7 mg/dL, ALT 81 U/L, Alk P 645 U/L], liver biopsy showing granulomatous hepatitis and liver tests improving but still abnormal 3 months later [ALT 44 U/L, Alk P 305 U/L]). 29082266
El Kahi C, Martinet V, Praet JP, Pepersack T. Un cas rare d’hépatotoxicité en gériatrie [A rare case of hepatotoxicity in geriatrics]. Rev Med Brux 2018; 39: 164-5. French. (Ordered: 12.26.2020). 29964389
Wu X, Yang F, Chen S, Xiong H, Zhu Q, Gao X, Xing Q, et al. Clinical, viral and genetic characteristics of drug reaction with eosinophilia and systemic symptoms (DRESS) in Shanghai, China. Acta Derm Venereol 2018; 98: 401-5. (Among 52 patients with DRESS syndrome seen at a referral hospital in Shanghai, China between 2011 and 2016, allopurinol was the most frequently implicated agent [n=18: 35%], followed by sulfasalazine [n=11: 21%] and carbamazepine [n=5; 10%]; rash was present in all patients, fever in 75%, eosinophilia in 81% and liver involvement in 83%; all allopurinol cases had HLA-B*58:01 and 2 had B*31:02, while sulfasalazine cases were linked to B*13:01 and carbamazepine to A*31:01 and B*13:01). 29242946
White WB, Saag KG, Becker MA, Borer JS, Gorelick PB, Whelton A, Hunt B, et al.; CARES Investigators. Cardiovascular safety of febuxostat or allopurinol in patients with gout. N Engl J Med 2018; 378: 1200-10. (Among 6190 patients with gout and cardiovascular disease treated with allopurinol or febuxostat for a median duration of 32 months, rates of overall cardiovascular events were similar in the two groups, but cardiovascular and all-cause mortality rates were higher in those on febuxostat, a surprising and unexplained outcome that was, nevertheless, supported by other studies). 29527974
Jung JW, Kim JY, Park IW, Choi BW, Kang HR. Genetic markers of severe cutaneous adverse reactions. Korean J Intern Med 2018; 33: 867-75. (Review of genetic associations with severe cutaneous reactions such as SJS and DRESS syndrome including the close association of allopurinol reactions and B*58:01; nevertheless, estimates from Korea suggest that only 18% of H*58:01 carriers develop allopurinol hypersensitivity reactions, indicating that other factors must play a role in the etiology). 29921043
Batista M, Cardoso JC, Oliveira P, Gonçalo M. Allopurinol-induced DRESS syndrome presented as a cholecystitis-like acute abdomen and aggravated by antibiotics. BMJ Case Rep 2018; 2018: bcr2018226023. (48 year old Caucasian man developed fever and right upper quadrant pain 4 weeks after starting allopurinol for gout [bilirubin not provided, ALT 575 U/L, Alk P 206 U/L, creatinine 1.24 mg/dL] leading to laparoscopic cholecystectomy which revealed a perforated gall bladder without stones; postoperatively he developed rash, eosinophilia and worsening liver and renal abnormalities, ultimately responding to systemic corticosteroids). 30042109
Wang YH, Chen CB, Tassaneeyakul W, Saito Y, Aihara M, Choon SE, Lee HY, et al.; Asian Severe Cutaneous Adverse Reaction Consortium. The medication risk of Stevens-Johnson Syndrome and toxic epidermal necrolysis in Asians: The major drug causality and comparison with the US FDA label. Clin Pharmacol Ther 2019; 105: 112-20. (Analysis of registration databases from multiple Asian countries between 1998 to 2017 identified 2018 cases of SJS/TEN, the most common causes being carbamazepine [26%], allopurinol [20%], phenytoin [13%], lamotrigine [10%], sulfamethoxazole [8%], aminopenicillins [3%], fluoroquinolones [2.5%], cephalosporins [2.3%], phenobarbital [2%] and multiple others). 29569740
Nguyen KD, Tran TN, Nguyen MT, Nguyen HA, Nguyen HA Jr, Vu DH, Nguyen VD, et al. Drug-induced Stevens-Johnson syndrome and toxic epidermal necrolysis in Vietnamese spontaneous adverse drug reaction database: a subgroup approach to disproportionality analysis. J Clin Pharm Ther 2019; 44: 69-77. (Among 136 spontaneous reports of SJS/TEN to a national Vietnamese registry between 2010 and 2015, 60% were male, mean age 42 years and 92% associated with a medication, most commonly carbamazepine [n=25], allopurinol [n=15] herbal medications [n=7], colchicine [n=4], valproate [n=3] and meloxicam [n=3]). 30129156
Devarbhavi H, Raj S. Drug-induced liver injury with skin reactions: Drugs and host risk factors, clinical phenotypes and prognosis. Liver Int 2019; 39: 802-11. (Review of drugs that cause liver injury with concurrent skin reactions such as DRESS syndrome and SJS/TEN mentions that allopurinol is one of the most common causes and is associated with HLA-B*58:01 in Han Chinese, this allele being rare in Europeans, Japanese and Africans). 30515930
Kang MG, Sohn KH, Kang DY, Park HK, Yang MS, Lee JY, Kang HR. Analysis of individual case safety reports of severe cutaneous adverse reactions in Korea. Yonsei Med J 2019; 60: 208-15. (Analysis of reports of serious cutaneous reactions to the Korean registry between 1988 and 2013 identified 755 cases [508 SJS/TEN, 247 DRESS], allopurinol being the most common cause of both [10% and 11%] followed by carbamazepine and others most of which were linked to both forms at similar rates; among 20 deaths, 2 were attributed to allopurinol [both SJS/TEN]). 30666843
Drugs for gout. Med Lett Drugs Ther 2019; 61(1567): 33-7. (Concise summary of the mechanism of action, clinical efficacy, safety and costs of drugs for gout discusses allopurinol as an agent to prevent flares that is widely used, often in inadequate doses, and with potentially serious side effects of severe cutaneous reactions, aminotransferase elevations and vasculitis and that Asian patients should be screened for HLA-A*58:01, a risk factor for SJS). 30845096
Sim DW, Yu JE, Jeong J, Jung JW, Kang HR, Kang DY, Ye YM, et al.; Korean Severe Cutaneous Adverse Reactions Consortium. Variation of clinical manifestations according to culprit drugs in DRESS syndrome. Pharmacoepidemiol Drug Saf 2019; 28: 840-8. (Among 123 cases of DRESS syndrome identified in a Korean registry for severe cutaneous reactions between 2011 and 2016, allopurinol accounted for 28 cases [23%], carbamazepine 22 [18%], antituberculosis agents 19 [15%], vancomycin 18 [15%], cephalosporins 15 [12%], dapsone 11 [9%], and NSAIDS 10 [8%]: allopurinol cases had a mean age of 56 years, 39% were women, 93% had eosinophilia, 86% had liver involvement and 79% renal, the mean latency was 30 days and there was only one death). 31044478
Park HJ, Yun J, Kang DY, Park JW, Koh YI, Kim S, Kim SH, et al.; Drug Allergy Work Group of KAAACI. Unique clinical characteristics and prognosis of allopurinol-induced severe cutaneous adverse reactions. J Allergy Clin Immunol Pract 2019; 7: 2739-2749.e3. (Among 106 subjects with a severe cutaneous reaction due to allopurinol reported to a national Korean registry between 2010 and 2015, those with SJS/TEN were older [71 vs 56 years], had a shorter latency [19 vs 29 days], and a higher mortality rate [17.6% vs 3.7%]). 31201937
Kreijne JE, de Veer RC, de Boer NK, Dijkstra G, West R, Moorsel SAW, de Jong DJ, et al.; of the Dutch Initiative on Crohn, Colitis (ICC). Real-life study of safety of thiopurine-allopurinol combination therapy in inflammatory bowel disease: myelotoxicity and hepatotoxicity rarely affect maintenance treatment. Aliment Pharmacol Ther 2019; 50: 407-15. (Among 221 patients with inflammatory bowel disease treated with low dose thiopurine combined with allopurinol, hepatotoxicity resolved in 86% of those with liver injury on thiopurine monotherapy but rose de novo in 31% of treated subjects, but was mostly mild [91%: ALT less than 3 times ULN] and self-limited in course, but was severe [ALT >5 times ULN] in 9 subjects and led to discontinuation in 2). 31359480
Zhang F, Liu Z, Jiang L, Zhang H, Zhao D, Li Y, Zou H, Wang X, Li X, Shi B, Xu J, Yang H, Hu S, Qu S. A randomized, double-blind, non-inferiority study of febuxostat versus allopurinol in hyperuricemic Chinese subjects with or without gout. Rheumatol Ther 2019; 6: 543-57. (Among 472 patients with hyperuricemia treated with titrated up doses of febuxostat [40 or 80 mg] or allopurinol [300 mg] for 24 weeks, response rates [uric acid 6.0 mg/dL or less] were highest with febuxostat 80 mg [63%] vs 40 mg [43%] and allopurinol[49%], while adverse event rates were similar including ALT elevations [6.5% vs 6.2% and 7.1%]). 31531831
Yang MS, Lee JY, Kim J, Kim GW, Kim BK, Kim JY, Park HW, et al. Searching for the culprit drugs for Stevens-Johnson syndrome and toxic epidermal necrolysis from a nationwide claim database in Korea. J Allergy Clin Immunol Pract 2020; 8: 690-695.e2. (Search using a Korean national health claims database identified 138 patients with SJS/TEN and the most commonly implicated agent was allopurinol [n=19]). 31614216
Myers CM, Miller JJ, Davis WD. Allopurinol-induced drug reaction with eosinophilia and systemic symptoms: a case report. Adv Emerg Nurs J 2020; 42: 108-18. (68 year old Chinese man developed rash and fever 3 weeks after starting allopurinol [100 mg daily] for asymptomatic hyperuricemia with eosinophilia and both renal and hepatic manifestations [bilirubin, ALT and Alk P not provided], responding ultimately to systemic corticosteroids). 32358426
Hakim C, Melitas C, Nguyen E, Ngo K. Atypical manifestation of DRESS syndrome. Case Rep Gastrointest Med 2020; 2020: PMID: 6863582. (52 year old African American man developed fever one week after completing a course of oral vancomycin and receiving allopurinol [unspecified duration and dose] during which he developed a rash and was treated with prednisone, which with tapering was followed by worsening fever and elevations in liver and kidney tests [bilirubin 0.6 mg/dL, ALT 1117 U/L, Alk P 169 U/L, creatinine 6.4 mg/dL, eosinophilia 13%], with subsequent spontaneous improvement).
Hasegawa A, Abe R. Recent advances in managing and understanding Stevens-Johnson syndrome and toxic epidermal necrolysis. F1000Res 2020; 9: F1000 Faculty Rev-612. (Review article on the pathogenesis of SJS/TEN and efficacy of immunosuppressive agents, focusing on possible role of intravenous immune globulin, cyclosporine and tumor necrosis factor antagonists).
Doria A, Galecki AT, Spino C, Pop-Busui R, Cherney DZ, Lingvay I, Parsa A, et al.; PERL Study Group. Serum urate lowering with allopurinol and kidney function in type 1 diabetes. N Engl J Med 2020; 382: 2493-503. (Among 530 patients with type 1 diabetes treated with allopurinol or placebo for 3 years, decline in renal function was similar in both groups as were overall and serious adverse event rates; one patient receiving allopurinol developed a serious hepatic adverse event, but no details were provided). 32579810
Kang DY, Yun J, Lee SY, Koh YI, Sim DW, Kim S, Nam YH, et al; Korean Severe Cutaneous Adverse Reactions Consortium. A nationwide study of severe cutaneous adverse reactions based on the multicenter registry in Korea. J Allergy Clin Immunol Pract 2020: S2213-2198(20) 30958-2. (Among 745 cases of severe cutaneous reactions to medication submitted to a national Korean registry between 2008 and 2016, 384 were for SJS and 361 DRESS, the most common cause of which was allopurinol [14%], carbamazepine [9.5%], vancomycin [4.7%] and antituberculosis agents [6.3%]; mortality rate was 6.6% [8.9% for SJS, 4.2% DRESS] and among 104 allopurinol implicated cases [51 SJS, 53 DRESS] the mortality was 11%).
Mackenzie IS, Ford I, Nuki G, Hallas J, Hawkey CJ, Webster J, Ralston SH, et al; FAST Study Group. Long-term cardiovascular safety of febuxostat compared with allopurinol in patients with gout (FAST): a multicentre, prospective, randomised, open-label, non-inferiority trial. Lancet 2020; 396(10264): 1745-57. (Among 6128 patients with gout and cardiovascular disease treated with either febuxostat or allopurinol for up to 7 years [mean 3.6 years], rates of combined cardiovascular endpoints were similar in the two groups [1.72 vs 2.05 events per 100 patient years] as were cardiovascular deaths [3.8% vs 4.0%]; no mention of hepatotoxicity in discussing causes of death or serious adverse events). 33181081
Yang L, Shou YH, Li F, Zhu XH, Yang YS, Xu JH. Retrospective study of 213 cases of Stevens-Johnson syndrome and toxic epidermal necrolysis from China. Burns. 2020;46:959-969.. (Among 213 patients with SJS seen at a single University Hospital in China between 2008 and 2018, common causes included carbamazepine [n=39], allopurinol [20], cephalosporins [16], penicillins [16], sulfonamides [14], various NSAIDs [20], and Chinese herbal medicines [11]). 31898979
Fontana RJ, Li YJ, Phillips E, Saeed N, Barnhart H, Kleiner D, Hoofnagle J; Drug Induced Liver Injury Network. Allopurinol hepatotoxicity is associated with human leukocyte antigen Class I alleles. Liver Int. 2021;41:1884-1893.. (Among 2027 patients with suspected drug-induced liver injury enrolled between 2003 and 2020 in a US database, 11 cases were attributed to allopurinol, 54% male, 63% African ancestry, median age 60 years, latency 52 days, initial ALT 525 U/L, Alk P 521 U/L, bilirubin 7.8 mg/dL, 6 patients had DRESS syndrome, 9 were treated with corticosteroids, 2 died with liver failure, cases were linked to HLA alleles B*58:01, B*53:01 and A*34:02). 33899326
Huang YS, Wu CY, Chang TT, Peng CY, Lo GH Hsu CW, Hu CT, et al. Drug-induced liver injury associated with severe cutaneous adverse drug reactions: A nationwide study in Taiwan. Liver Int. 2021;41:2671-2680.. (Among 1415 patients with drug-induced liver injury enrolled in a multicenter prospective study in Taiwan between 2011 and 2020, 158 had an accompanying serious cutaneous adverse reaction (SCAR], most frequently due allopurinol with 39 cases [28 SJS/TEN, 11 DRESS], HLA-B*58:01 being present in 38 allopurinol cases; and overall independent risk factors for mortality were jaundice, acute renal injury and SJS/TEN but not age, sex, alcohol use, or pre-existing liver disease). 34153177
Villanueva-Paz M, Niu H, Segovia-Zafra A, Medina-Caliz I, Sanabria-Cabrera J, Lucena MI, Andrade RJ, et al. Critical review of gaps in the diagnosis and management of drug-induced liver injury associated with severe cutaneous adverse reactions. J Clin Med. 2021;10:5317.. (Review of the challenges in analysis of severe cutaneous adverse reactions [SCAR] among patients with drug-induced liver injury pointing out the variability of specific drug causes such as allopurinol which is reported in 6% to 33% in case series, varying by race, by definitions of SCAR, and by criteria of significant liver injury for enrollment). 34830594
Liu Q, Zhao S, Chen W. Clinical features, treatment outcomes and prognostic factors of allopurinol-induced DRESS in 52 patients. J Clin Pharm Ther. 2022;47:1368-1378.. (Among 52 cases of allopurinol induced DRESS syndrome published in the Chinese literature, 79% were male, mean age 56 years, latency 25 [range 1 to 63] days, all had skin rash, 96% fever, 50% facial edema, 39% lymphadenopathy, 90% liver involvement, 88% eosinophilia, 23% mortality from DRESS which was higher with older age and multiple organ involvement). 35971667
Medina-Cáliz I, Sanabria-Cabrera J, Villanueva-Paz M, Aukštikalnė L, Stephens C, Robles-Díaz M, Pinazo-Bandera JM, et al. Characterization of drug-induced liver injury associated with drug reaction with eosinophilia and systemic symptoms in two prospective DILI registries. Arch Toxicol. 2024;98:303-325.. (Among 1437 patients identified in the Spanish and Latin American drug induced liver injury registries, 53 presented with DRESS syndrome, the most common causes of which were carbamazepine, drugs for tuberculosis, amoxicillin-clavulanate, lamotrigine, and allopurinol [4 cases of the 6 liver injury cases that implicated allopurinol]). 38051367
Mąsior MN, Rostkowska OM, Furmańczyk-Zawiska A, Wieczorek-Godlewska R, Wyzgał M, Durlik M. DRESS syndrome: renal involvement in two cases - a comprehensive analysis and literature review of improved diagnosis and treatment. Am J Case Rep. 2024;25:e942315.. (37 year old Vietnamese woman with chronic renal disease developed an extensive body rash, sore throat, and fever 2 weeks after starting allopurinol for hyperuricemia [bilirubin not given, ALT 396 U/L, GGT 76 U/L, renal function worsening, eosinophils normal, then rising to 1330/μL] treated with corticosteroids with eventual resolution; later found to have HLA-B*58:01). 38204155
Prasai P, Shakya S, Singh A, Manandhar S, Adhikari B. Stevens-Johnson syndrome associated with pancytopenia: a case report. Ann Med Surg (Lond). 2024;86:4291-4294. (61 year old Nepalese man developed rash [involving 7% of body surface, including oral mucosa and conjunctiva] with fever, 28 days after starting allopurinol [bilirubin 1.5 mg/dL, ALT 131 U/L, Alk P not given, eosinophils 10%] treated with corticosteroids with rapid recovery within a few weeks). 38989185
Torgersen J, Mezochow AK, Newcomb CW, Carbonari DM, Hennessy S, Rentsch CT, Park LS, et al. Severe acute liver injury after hepatotoxic medication initiation in real-world data. JAMA Intern Med. 2024;184:943-952.. (Analysis of the US Veterans Administration electronic health records between 1999 and 2021 identified 1739 hospitalizations for acute liver injury suspected to be due to medications and estimated the incidence of allopurinol induced liver injury to be 1 per 5,600 patients exposed). 38913369
Chen VL, Rockey DC, Bjornsson ES, Barnhart H, Hoofnagle JH; Drug-Induced Liver Injury Network Investigators. Incidence of idiosyncratic drug-induced liver Injury caused by prescription drugs. Drug Saf. 2025;48:151-160.. (Analysis of 1284 cases of drug-induced liver injury, enrolled between 2005 and 2019 in a U.S. prospective study, identified 12 [1%] cases of due to allopurinol making it rank as the 21^st^ most frequently implicated drug and estimating its incidence as 1 per 4,100 newly exposed patients). 39317916
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 483 cases of drug-induced liver injury enrolled between 2011 and 2021 in a prospective Latin American database, 6 cases [1.5%] were attributed to allopurinol). 38992407
Lammert C, Teal E, Ghabril M, Chalasani N. Incidence of possible drug-induced liver injury due to commonly implicated agents in the United States. Clin Gastroenterol Hepatol. 2025;23:1061-1062.e1.. (Analysis of a health database of 16 Indiana University Health hospitals, identified 54 cases of drug-induced liver injury caused by 9 commonly implicated agents, allopurinol ranking sixth with 4 cases among 14,949 persons exposed for an incidence of 1 per 3,736). 39447947
Brooks C, Calderon L, Mosunjac M, Qayed E. Acute immunoallergic hepatitis due to allopurinol use. Hepatol Forum. 2025;6:65-68.. (21 year old Vietnamese male developed skin rash 6 weeks after starting allopurinol for gout with progression of rash to involve most of body, followed by fever, facial edema, adenopathy, and jaundice [bilirubin 3.1 rising to 18.7 mg/dL, ALT 502 to 1528, Alk P 243, HLA-B*58:01 positive], treated with corticosteroids and prompt resolution with normal liver tests 50 days later). 40248680
Li K, Lauschke VM, Zhou Y. Molecular docking to investigate HLA-associated idiosyncratic drug reactions. Drug Metab Rev. 2025;57:67-90.. (Review of studies of molecular docking of drugs implicated in idiosyncratic drug reactions with the associated HLA alleles including the example of allopurinol and HLA-B*58:01). 39811883
Rahnama-Moghadam S, Arora N, Vuppalanchi R, Li YJ, Gu J, Barnhart H, Phillips E, et al; Drug Induced Liver Injury Network. DRESS syndrome in patients with drug-induced liver injury: characteristics and HLA risk factors. Am J Gastroenterol. 2025 Jun 12. epub ahead of print.. (Among 2121 patients enrolled between 2004 and 2023 in a US prospective study of drug-induced liver injury, 128 [6%] had DRESS syndrome, 7 of whom were due to allopurinol; DRESS cases being linked to HLA alleles A*32:01, B*53:01, and B*58:01, the latter two most closely being linked with allopurinol cases. 40504263

## OTHER REFERENCE LINKS

1. Recent References on Allopurinol: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Allopurinol/AE+AND+Human%5BMH%5D+AND+(drug-induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%222010/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Allopurinol: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Allopurinol)